# Asenapine

## OVERVIEW

### Introduction

Asenapine is a second generation (atypical) antipsychotic agent that is taken sublingually and used in the treatment of schizophrenia and manic or mixed episodes associated with bipolar 1 disorder. Asenapine is associated with a low rate of transient and mild serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent acute liver injury.

### Background

Asenapine (a sen' a peen) is a second generation antipsychotic agent which appears to act as a dopamine type 2 (D2) and serotonin (5-HT)-2A receptor antagonist. It is a somewhat unique antipsychotic agent that has a tetracyclic structure similar to that of mirtazapine, and it is administered as a sublingual tablet, being poorly absorbed by the oral route. Several randomized controlled trials have shown that sublingual asenapine improves symptoms of schizophrenia with effects comparable to risperidone and olanzapine. It also has beneficial activity in acute manic and mixed episodes associated with bipolar 1 disorder. Asenapine was approved for use in the United States in 2009 and is available in sublingual tablets of 2.5, 5 and 10 mg generically and under the brand name Saphris. The typical maintenance dose in adults is 2.5 to 10 mg twice daily. Asenapine is also available for treatment of schizophrenia as a transdermal formulation available in doses of 3.8, 5.7 and 7.6 mg per 24 hours under the brand name Secuado. The recommended initial dose of the transdermal patch is 3.8/24 hours, which can be increased to 5.7/24 hours and 7.6 mg/24 hours based upon effect and tolerance. Common side effects of asenapine include dizziness, somnolence, fatigue, nausea, anxiety, restlessness (akathisia) and weight gain. Rare, but potentially severe adverse reactions (mentioned in most antipsychotic and antidepressant product labels) include tardive dyskinesia, major neurologic events, neuroleptic malignant syndrome, orthostatic hypotension, seizures, neutropenia, hypersensitivity reactions, prolongation of the QTc interval, increased cerebrovascular events, and suicidal ideation or behavior. Asenapine also has a boxed warning of increased mortality in elderly patients with dementia-related psychosis.

### Hepatotoxicity

Liver test abnormalities occur in 1% to 2.5% of patients receiving asenapine, but similar rates are reported with placebo therapy (0.6% to 1.3%) and with comparator agents. The ALT elevations are usually mild, transient and often resolve even without dose modification or drug discontinuation. There has been a single case report of cholestatic serum enzyme elevations arising 3 to 4 weeks after starting asenapine, resolving within a month of stopping. Thus, asenapine may be a rare cause of mild cholestatic liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which asenapine might cause serum enzyme elevations or liver injury is not known. Asenapine is metabolized to some extent by the cytochrome P450 system (CYP 2D6 and 3A4), but is an uncommon cause of significant drug-drug interactions with agents that inhibit or induce these microsomal enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur with asenapine therapy are usually self-limited and often do not require dose modification or discontinuation. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to asenapine. Cross sensitivity to liver related or other hypersensitivity reactions between asenapine and other antipsychotic agents have not been demonstrated.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Asenapine – Saphris®, Secuado®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Asenapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Asenapine | 65576-45-6 | C17-H16-Cl-N-O

## ANNOTATED BIBLIOGRAPHY

References updated: 05 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Larry D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of psychiatric agents, does not discuss asenapine).
Potkin SG, Cohen M, Panagides J. (2007). Efficacy and tolerability of asenapine in acute schizophrenia: a placebo- and risperidone-controlled trial. J Clin Psychiatry. (Among 174 patients with acute schizophrenia treated with sublingual asenapine [5 mg] or risperidone [3 mg] or placebo twice daily for 6 weeks, symptom scores improved more with asenapine and risperidone than with placebo, although adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo controlled trials [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, 0.6 risperidone, -0.3 ziprasidone; a 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects; no mention of asenapine).
McIntyre RS, Cohen M, Zhao J, Alphs L, Macek TA, Panagides J. (2009). A 3-week, randomized, placebo-controlled trial of asenapine in the treatment of acute mania in bipolar mania and mixed states. Bipolar Disord. (Among 480 adults with an acute manic or mixed episode in a prospective controlled trial for 3 weeks, there was rapid improvement in symptoms with sublingual asenapine [5 mg] and oral olanzapine [3 mg] compared to placebo twice daily; ALT levels increase by 12 U/L on average with asenapine, 33 U/L with olanzapine, but decrease by 7 U/L with placebo, although none of the changes were considered “clinically relevant”).
McIntyre RS, Cohen M, Zhao J, Alphs L, Macek TA, Panagides J. (2010). Asenapine in the treatment of acute mania in bipolar I disorder: a randomized, double-blind, placebo-controlled trial. J Affect Disord. (Among 488 adults with acute mania and bipolar 1 disorder treated with asenapine, olanzapine or placebo for 3 weeks, symptoms score improved more in the asenapine than placebo recipients and “mean changes from baseline in laboratory values…were not clinically significant”).
(2010). Asenapine (Saphris) sublingual tablets for schizophrenia and bipolar disorder. Med Lett Drugs Ther. (Concise review of the mechanism of action, pharmacology, efficacy, safety and costs of asenapine as therapy of schizophrenia and bipolar disorder shortly after its approval for use in the US, mentions side effects of akathisia, oral hypoesthesia, somnolence, dizziness and weight gain; no mention of ALT elevations or hepatotoxicity).
Potkin SG. (2011). Asenapine: a clinical overview. J Clin Psychiatry. (Review and overview of the pharmacology, clinical efficacy and safety of sublingual asenapine for treatment of schizophrenia and acute mania mentions occasional hypersensitivity reactions and problems of weight gain with long term therapy; no mention of ALT elevations or hepatotoxicity).
(2012). Asenapine: a less effective, yet more dangerous neuroleptic!. Prescrire Int. (Short commentary on use of asenapine in bipolar disorders mentions that asenapine has more adverse side effects than other neuroleptics, and these include oral hypoesthesia and hypersensitivity reactions that can be severe).
Cazorla P, Mackle M, Zhao J, Ha X, Szegedi A. (2012). Safety and tolerability of switching to asenapine from other antipsychotic agents: pooled results from two randomized multicenter trials in stable patients with persistent negative symptoms in schizophrenia. Neuropsychiatr Dis Treat. (Among 949 adults with schizophrenia who were switched from standard antipsychotic agents to asenapine or olanzapine in two 26-week controlled trials, common side effects in the first month included somnolence [10% vs 13%], insomnia [17% vs 12%], and headache [14% vs 10%], while serious adverse events occurred in 12% on asenapine and 6% on olanzapine, although no specifics given or mention made of ALT elevations).
Schoemaker J, Stet L, Vrijland P, Naber D, Panagides J, Emsley R. (2012). Long-term efficacy and safety of asenapine or olanzapine in patients with schizophrenia or schizoaffective disorder: an extension study. Pharmacopsychiatry. (Among 440 patients with schizophrenia or schizoaffective disorder who were continued on asenapine or olanzapine after a 52 week controlled trial, adverse events were common, but less frequent than during the initial year of treatment, and there were “no major changes in laboratory variables including … liver enzymes”).
Potkin SG, Phiri P, Szegedi A, Zhao J, Alphs L, Cazorla P. (2013). Long-term effects of asenapine or olanzapine in patients with persistent negative symptoms of schizophrenia: a pooled analysis. Schizophr Res. (Among 502 patients with schizophrenia treated with asenapine or olanzapine in two clinical trials for 26 weeks with another 26 week extension study, adverse events were not discussed in detail and no mention made of ALT elevations or hepatotoxicity).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise review of safety, efficacy and role of drugs for psychiatric disorders mentions that asenapine is a second generation antipsychotic agent whose adverse side effects include insomnia, somnolence, nausea, vomiting and weight gain; no mention of ALT elevations or hepatotoxicity).
Kemp DE, Zhao J, Cazorla P, Landbloom RP, Mackle M, Snow-Adami L, Szegedi A. (2014). Weight change and metabolic effects of asenapine in patients with schizophrenia and bipolar disorder. J Clin Psychiatry. (Among 1748 patients with schizophrenia or bipolar illness treated in 17 clinical trials, post hoc analyses of weight change showed greater gain with asenapine than placebo during the initial 4 week period [1.2 vs 0.4 kg], but less than with olanzapine [0.9 vs 3.0 kg]; no mention of changes of ALT levels with weight gain).
Musil R, Obermeier M, Russ P, Hamerle M. (2015). Weight gain and antipsychotics: a drug safety review. Expert Opin Drug Saf. (Extensive systematic review of the literature on the problem of weight gain during therapy with antipsychotic agents mentions that asenapine has been linked to weight gain and increase in body weight of 7% or more occurs in 3.7-39.2% of patients).
Landbloom RL, Mackle M, Wu X, Kelly L, Snow-Adami L, McIntyre RS, Mathews M, et al. (2016). Asenapine: Efficacy and safety of 5 and 10 mg bid in a 3-week, randomized, double-blind, placebo-controlled trial in adults with a manic or mixed episode associated with bipolar I disorder. J Affect Disord. (Among 367 patients with a manic or mixed episode associated with bipolar 1 disorder treated with asenapine [5 or 10 mg] or placebo twice daily for 3 weeks, symptoms were somewhat more improved with asenapine than placebo, while adverse events were more frequent, particularly somnolence [20% and 26% vs 4%] and oral hypoesthesia [16% and 29% vs 2%], although “no patients had elevated liver enzymes that met criteria for potential drug-induced liver injury”).
Findling RL, Landbloom RP, Mackle M, Pallozzi W, Braat S, Hundt C, Wamboldt MZ, et al. (2015). Safety and efficacy from an 8 week double-blind trial and a 26 week open-label extension of asenapine in adolescents with schizophrenia. J Child Adolesc Psychopharmacol. (Among 306 adolescents with schizophrenia treated with asenapine [2.5 or 5 mg] or placebo twice daily for 8 weeks, some symptom scores improved with the higher dose of asenapine compared to placebo, but adverse events were also more common including akathisia, dizziness, oral hypoesthesia, insomnia and weight gain; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 patients with drug induced liver injury seen over a ten year period at 8 US medical centers, one case was attributed to olanzapine, but none to asenapine or other atypical antipsychotic medications).
Schultz K, Wang L, Barr A, Vila Rodriguez F. (2015). A case of pseudo-Stauffer's syndrome related to asenapine use. Schizophr Res. (50 year old man developed abnormal liver tests 24 days after starting asenapine [bilirubin and ALT not given; Alk P 508 U/L, GGT 904 U/L], which persisted despite stopping valproate and then resolved within a month of stopping asenapine).
Findling RL, Landbloom RL, Mackle M, Wu X, Snow-Adami L, Chang K, Durgam S. (2016). Long-term safety of asenapine in pediatric patients diagnosed with bipolar I disorder: A 50-week open-label, flexible-dose trial. Paediatr Drugs. (Among 321 pediatric patients [ages 10 to 17 years] with bipolar disorder were treated with sublingual asenapine for up to one year, side effects were generally mild but led to early discontinuation in 15% of patients; no mention of ALT elevations or hepatotoxicity).
Ketter TA, Durgam S, Landbloom R, Mackle M, Wu X, Mathews M. (2017). Long-term safety and tolerability of asenapine: A double-blind, uncontrolled, long-term extension trial in adults with an acute manic or mixed episode associated with bipolar I disorder. J Affect Disord. (Among 164 adults with bilar disorder enrolled in a 26 week extension study after a placebo controlled 3 week trial of asenapine, adverse events were mostly neuropsychiatric and weight gain; no mention of ALT elevations or hepatotoxicity).
Szegedi A, Durgam S, Mackle M, Yu SY, Wu X, Mathews M, Landbloom RP. (2018). Randomized, double-blind, placebo-controlled trial of asenapine maintenance therapy in adults with an acute manic or mixed episode associated with bipolar I disorder. Am J Psychiatry. (Among 253 patients with acute manic or mixed episodes treated with asenapine [10 mg twice daily] for 12-16 weeks and if they responded were then continued therapy or were switched to placebo, recurrence of manic, mixed, or depressive episodes were less frequent with continuing sublingual asenapine than switching to placebo, and adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Citrome L, Walling DP, Zeni CM, Starling BR, Terahara T, Kuriki M, Park AS, et al. Efficacy and safety of HP-3070, an asenapine transdermal system, in patients with schizophrenia: a phase 3, randomized, placebo-controlled study. J Clin Psychiatry. 2020;82:20m13602. (Among 614 patients with an acute exacerbation of schizophrenia treated with transdermal asenapine [3.8 or 7.6 mg/24 hours] or placebo for 6 weeks, symptom scores improved more with both doses of asenapine compared with placebo and adverse event rates were similar with no serious adverse events; no mention of ALT elevations or hepatotoxicity).
(2021). In brief: An asenapine patch (Secuado) for schizophrenia. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, toxicity and cost of transdermal asenapine shortly after its approval as therapy of schizophrenia in the US; no mention of ALT elevations or hepatotoxicity).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).

## OTHER REFERENCE LINKS

1 Recent References on Asenapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Asenapine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Asenapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Asenapine)